# Pentamidine

## OVERVIEW

### Introduction

Pentamidine is a potent, broad spectrum antiinfective agent with activity against several parasitic worms, protozoa and fungi that has been used mainly in the treatment and the prophylaxis of Pneumocystis jiroveci (formerly carinii) infection in immunocompromised persons. Pentamidine is relatively toxic and therapy requires careful monitoring. Pentamidine has been associated with transient serum aminotransferase elevations during therapy and with rare instances of clinically apparent liver injury.

### Background

Pentamidine (pen tam' i deen) is an aromatic diamine that is active against a broad spectrum of infectious agents. Its mechanism of action is unknown, but it appears to be taken up and concentrated within microorganisms where it inhibits DNA, RNA and protein synthesis. Pentamidine has a broad spectrum of activity against several cestodes, trematodes and protozoan parasites such as Giardia, Cryptosporidium and Entamoeba. Pentamidine is also active against Pneumocystis jiroveci (formerly known as P. carinii), which is now considered a fungal agent. Pentamidine was approved for use in the United States in 1984 at which time a major indication was the prophylaxis and therapy of Pneumocystis jiroveci infection. In intervening years, pentamidine has been replaced by better tolerated and less toxic agents in treating Pneumocystis such as trimethoprim/sulfamethoxazole or dapsone with atovaquone. Pentamidine is also an alternative, second line therapy for leishmaniasis and trypanosomiasis. Pentamidine is not absorbed well by the oral route and is available in aerosol forms (300 mg) under the brand name of Nebupent and as a solution for injection under the name Pentam 300. For treatment of pneumocystis pneumonia, the recommended regimen is 3-4 mg/kg intravenously or intramuscularly once daily for 14 to 21 days. For pneumocystis prevention, the recommended regimen is 300 mg in nebulized form every 4 weeks. Pentamidine therapy is highly toxic and the side effects of intravenous therapy are often severe and can be fatal. These side effects include nausea, abdominal discomfort, dizziness, hypotension, tachycardia, headache, rash, fever, hypoglycemia, hyponatremia, renal insufficiency and allergic reactions, including Stevens Johnson syndrome.

### Hepatotoxicity

Pentamidine has been associated with serum aminotransferase elevations in 9% to 15% of patients receiving 2 to 3 weeks of therapy for pneumocystis pneumonia. Clinically apparent liver injury has also been reported with its use, but always in association with multiple other severe complications, such as respiratory or renal failure and pancreatitis. The onset of injury is within days of starting therapy and is characterized by acute hepatic necrosis, marked elevations in serum aminotransferase levels, rapid development of prolongation of prothrombin time and minimal or no jaundice. Recovery is typically rapid and usually complete.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Pentamidine interferes with polyamine synthesis and RNA polymerase activity, which may account for its multiorgan toxicity.

### Outcome and Management

Pentamidine is not very well tolerated, but its major toxicities are not hepatic, and the predominance of these other dose limiting toxicities may be the reason that liver injury is not more common. Pentamidine has not been associated with fatal acute liver failure or chronic liver injury.

Drug Class: Antifungal Agents

Pentamidine is not a typical antifungal agent and has a broad spectrum of activity that does not fit neatly into any antimicrobial class. Other agents used to treat or prevent Pneumocystis jiroveci pneumonia:

Sulfamethoxazole/Trimethoprim, Dapsone, Atovaquone, Primaquine, Clindamycin

Drug Class: Anthelmintic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pentamidine – NebuPent® [Aerosol]

DRUG CLASS

Antifungal/Anthelmintic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=pentamidine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Pentamidine | 100-33-4 | C19-H24-N4-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 20 July 2020

Zimmerman HJ. Antifungal agents. Hepatic injury from antimicrobial agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 609-11. (Expert review of hepatotoxicity of antifungal agents written in 1999; severe cases of liver injury have been reported in patients with AIDS receiving pentamidine).
Wetzel DM, Phillips MA. Chemotherapy of protozoal infections: amebiasis, giardiasis, trichomoniasis, trypanosomiasis, leishmaniasis, and other protozoal infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 985-99. (Textbook of pharmacology and therapeutics).
National Library of Medicine, NIH. http://aidsinfo.nih.gov/guidelines/ (Web site with recent guidelines on management and prevention of opportunistic infections including P. jiroveci in persons with HIV infection).
Waalkes TP, Denham C, Devita VT. (1970). Pentamidine: clinical pharmacologic correlations in man and mice. Clin Pharmacol Ther. (Analysis of pharmacokinetics and toxicity of pentamidine in 7 patients with cancer being treated for P. jiroveci pneumonia; minor changes in liver enzymes were noted in some patients).
Western KA, Perera DR, Schultz MG. (1970). Pentamidine isethionate in the treatment of Pneumocystis carinii pneumonia. Ann Intern Med. (Among 164 patients with P. jiroveci pneumonia treated with pentamidine, 42% had side effects including 12 [7%] with abnormal liver tests; AST 48-170 U/L, but 1 patient had jaundice and AST 2000 2 weeks after stopping, ultimately resolving at least in part ).
Picon M, Causse X, Gelas P, Retornaz G, Trépo C, Bouletreau P. (1991). Gastroenterol Clin Biol. (27 year old with HIV infection and severe P. jiroveci pneumonia developed renal insufficiency, pancreatitis [amylase 623 U/L] and acute hepatic necrosis after 6 days of intravenous pentamidine, with ALT 2000 U/L and decrease in prothrombin time with rapid recovery upon stopping).
Balslev U, Nielsen TL. (1992). Adverse effects associated with intravenous pentamidine isethionate as treatment of Pneumocystis carinii pneumonia in AIDS patients. Dan Med Bull. (Retrospective analysis of side effects of pentamidine therapy in 21 patients with AIDS and P. jiroveci infection; serum enzyme elevations occurred in 3 patients but were minor; major side effects [n=5] included hypoglycemia, pancreatitis and cardiac arrest).
O'Brien JG, Dong BJ, Coleman RL, Gee L, Balano KB. (1997). A 5-year retrospective review of adverse drug reactions and their risk factors in human immunodeficiency virus-infected patients who were receiving intravenous pentamidine therapy for Pneumocystis carinii pneumonia. Clin Infect Dis. (Retrospective analysis of adverse drug reactions to intravenous pentamidine therapy of Pneumocystis jiroveci pneumonia, identified 174 events in 72% of 106 patients treated with pentamidine; most common were nephrotoxicity [48%], hypoglycemia [24%], hyperkalemia [19%] and serum enzyme elevations [15%]).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, only one of which was attributed to an anthelmintic, mebendazole; none were attributed to pentamidine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 409 [46%] were attributed to antimicrobial agents, but none to anthelmintics or to pentamidine ).
Pohlig G, Bernhard SC, Blum J, Burri C, Mpanya A, Lubaki JP, Mpoto AM, et al. (2016). Efficacy and safety of pafuramidine versus pentamidine maleate for treatment of first stage sleeping sickness in a randomized, comparator-controlled, international phase 3 clinical trial. PLoS Negl Trop Dis. (Among 273 patients with human African trypanosomiasis treated with pafuramidine or pentamidine, cure rates were higher with pentamidine [95% vs 89%] as were ALT elevations [52% vs 1.5%]; no mention of hepatotoxicity).
Solodokin LJ, Klejmont LM, Scipione MR, Dubrovskaya Y, Lighter-Fisher J, Papadopoulos J. (2016). Safety and effectiveness of intravenous pentamidine for prophylaxis of pneumocystis jirovecii pneumonia in pediatric hematology/oncology patients. J Pediatr Hematol Oncol. (Among 121 children with hematologic malignancies treated with intravenous pentamidine as prophylaxis, none developed pneumocystis jirovecii infection and 19 [16%] developed adverse events that led to discontinuation in 5 [4%], but none were hepatic related, and there were no “clinically significant changes in blood chemistry levels”).
Huang YS, Yang JJ, Lee NY, Chen GJ, Ko WC, Sun HY, Hung CC. (2017). Treatment of Pneumocystis jirovecii pneumonia in HIV-infected patients: a review. Expert Rev Anti Infect Ther. (Review of pneumocystis pneumonia in HIV-infected patients and its prevention and management, trimethoprim-sulfamethoxazole being the treatment of choice, pentamidine being a second line option, but which requires slow intravenous administration and which has many adverse events most commonly renal injury, hyperkalemia, hypoglycemia, neutropenia and torsades de pointes; no mention of ALT elevations or hepatotoxicity).
Sweiss K, Anderson J, Wirth S, Oh A, Quigley JG, Khan I, Saraf S, et al. (2018). A prospective study of intravenous pentamidine for PJP prophylaxis in adult patients undergoing intensive chemotherapy or hematopoietic stem cell transplant. Bone Marrow Transplant. (Among 50 adult patients with hematologic malignancies undergoing chemotherapy or hematopoietic cell transplantation treated with prophylactic intravenous pentamidine [4 mg/kg] monthly, none developed pneumocystis pneumonia and there were no severe adverse events, although therapy was temporarily interrupted in 2 subjects [one for nausea and one for facial numbness] and there was no mention of ALT elevations or hepatotoxicity).
Gadelha EPN, Ramasawmy R, da Costa Oliveira B, Morais Rocha N, de Oliveira Guerra JA, Allan Villa Rouco da Silva G, Gabrielle Ramos de Mesquita T, et al. (2018). An open label randomized clinical trial comparing the safety and effectiveness of one, two or three weekly pentamidine isethionate doses (seven milligrams per kilogram) in the treatment of cutaneous leishmaniasis in the Amazon Region. PLoS Negl Trop Dis. (Among 159 patients with American Cutaneous Leishmaniasis treated with 1, 2 or 3 weekly infusions of pentamidine [7 mg/kg], cure rates were 45%, 81% and 96% and side effects were common but mild and did not result in any early discontinuations; no mention of ALT elevations or hepatotoxicity).
Wilcox MA, Hardin J, Weaver J, Voss EA. (2019). Liver test monitoring: real-world compliance for drugs with monitoring requirements at 2-week intervals or more frequently. Pharmaceut Med. (Analysis of 3 large health databases for compliance with recommendations for liver test monitoring when initiating therapy with 9 drugs found compliance was highest for oxaliplatin [75%], somewhat lower for rifampin [68%], tolcapone [67%], albendazole [66%] and azathioprine [61%], and poor for pentamidine [21%], felbamate [22%], succimer [29%] and ketoconazole [32%]).

## OTHER REFERENCE LINKS

1 Recent References on Pentamidine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Pentamidine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Pentamidine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pentamidine)